# Molindone

## OVERVIEW

### Introduction

Molindone is a conventional antipsychotic agent used in the therapy of schizophrenia. Molindone therapy is commonly associated with minor serum aminotransferase elevations but has rarely been linked to cases of clinically apparent acute liver injury.

### Background

Molindone (moe lin' done) is a dihydroindolone antipsychotic medication that is not structurally related to the phenothiazines and which appears to act by blocking dopamine type 2 (D2) receptors. Molindone has other central and peripheral effects including anticholinergic and alpha adrenergic blockade. Molindone was approved for use in the therapy of psychotic disorders in the United States in 1974. Since then, however, molindone has been replaced in large part by the atypical antipsychotics, which have fewer extrapyramidal side effects. Molidone is no longer frequently used, but remains available as tablets of 5, 10, 25 and 50 mg generically and previously under the brand name Moban. Recommended doses of molindone were 50 to 75 mg daily initially, increasing based upon efficacy and tolerance to as high as 225 mg daily. Common side effects included drowsiness, dizziness, headache, blurred vision, dry mouth, and tremor. Less common but potentially severe adverse events include extrapyramidal symptoms, akathisia, tardive dyskinesia, neuroleptic malignant syndrome, leukopenia, agranulocytosis, falls and excess mortality in elderly subjects with dementia.

### Hepatotoxicity

Liver test abnormalities have been reported to occur in a small proportion of patients on long term therapy with molindone, but elevations are uncommonly above 3 times the upper limit of normal. The aminotransferase abnormalities are usually mild, asymptomatic and transient, reversing even with continuation of medication. Instances of clinically apparent acute liver injury have been reported due to molindone, but are rare. The onset of injury is within 4 to 8 weeks, and the pattern of serum enzyme elevations is typically hepatocellular. Jaundice is uncommon and most cases are self-limited and mild. Immunoallergic features and autoantibody formation are not typical.

Likelihood score: D (possible, rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which molindone causes serum aminotransferase elevations is not known, but is likely due to production of a toxic intermediate by its metabolism. Molindone is extensively metabolized by the liver via sulfoxidation and oxidation, but has not been implicated in clinically significant drug-drug interactions.

### Outcome and Management

The serum aminotransferase elevations that occur on molindone therapy are usually self-limited and do not require dose modification or discontinuation of therapy. No instances of acute liver failure or vanishing bile duct syndrome due to molindone have been reported. Patients with molindone induced liver injury probably do not have cross sensitivity to atypical antipsychotics.

Drug Class: Antipsychotic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Molindone – Generic, Moban®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=1275e92f-9573-4d0c-8e77-1c9ac47696d2)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Molindone | 7416-34-4 | C16-H24-N2-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 21 January 2020

Zimmerman HJ. Neuroleptic drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 483-91. (Expert review of hepatotoxicity of neuroleptic drugs including molindone published in 1999; mentions that molindone can cause serum aminotransferase elevations and has been linked to rare cases of clinically apparent cases of liver injury).
Larrey D, Ripault MP. Molindone. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 455. (Review of hepatotoxicity of psychiatric agents mentions mentions a single case of clinically apparent liver injury due to molindone).
Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
Kellner R, Rada RT, Egelman A, Macaluso B. (1976). Long-term study of molindone hydrochloride in chronic schizophrenics. Curr Ther Res Clin Exp. (Open label study of molindone for 6 months in 23 patients; 2 had minimal ALT elevations; no details given).
Bhatia SC, Banta LE, Ehrlich DW. (1985). Molindone and hepatotoxicity. Drug Intell Clin Pharm. (17 year old male developed fever and fatigue 4 weeks after starting molindone [bilirubin 0.3 mg/dL, ALT 694 U/L, Alk P 100 U/L], resolving within 3 weeks of stopping; rechallenge for 4 days led to ALT elevations [134 U/L]; patient later tolerated thioridazine; authors mention 11 previous instances of hepatotoxicity, all of which were asymptomatic and self-limited).
Claghorn JL. (1985). Review of clinical and laboratory experiences with molindone hydrochloride. J Clin Psychiatry. (Review of pharmacokinetics, mechanism of action and efficacy of molindone; no mention of hepatic side effects).
Munyon WH, Salo R, Briones DF. (1987). Cytotoxic effects of neuroleptic drugs. Psychopharmacology (Berl). (In vitro testing for cytotoxicity suggested that the phenothiazines are the most, haloperidol intermediate and loxapine and molindone the least toxic).
Allison DB, Mentore JL, Heo M, Chandler LP, Cappelleri JC, Infante MC, Weiden PJ. (1999). Antipsychotic-induced weight gain: a comprehensive research synthesis. Am J Psychiatry. (Systematic review of 81 articles on weight change with antipsychotics, using change after 10 weeks to compare agents: clozapine +5.7, olanzapine +4.2, chlorpromazine +4.2, risperidone +1.7, loxapine +0.6, haloperidol +0.5, ziprasidone +0.3, molindone -0.1, and pimozide -2.7 kg).
Bagnall A, Fenton M, Kleijnen J, Lewis R. (2007). Molindone for schizophrenia and severe mental illness. Cochrane Database Syst Rev. (Cochrane review of efficacy and safety; no mention of hepatotoxicity or serum ALT elevations).
Sikich L, Frazier JA, McClellan J, Findling RL, Vitiello B, Ritz L, Ambler D, et al. (2008). Double-blind comparison of first- and second-generation antipsychotics in early-onset schizophrenia and schizo-affective disorder: findings from the treatment of early-onset schizophrenia spectrum disorders (TEOSS) study. Am J Psychiatry. (Prospective trial of molindone [1st generation] vs olanzapine or risperidone [2nd generation] for schizophrenia in 119 youths found similar rates of efficacy [34-50%], but more weight gain [mean 6.1 kg] and ALT elevations with olanzapine).
Torrent C, Amann B, Sanchez-Moreno J, Colom F, Feinares M, Comes M, Rosa AR, et al. (2008). Weight gain in bipolar disorder: pharmacological treatment as a contributing factor. Acta Psychiatr Scand. (Review of frequency of weight gain in patients treated for bipolar disorders, most weight gain occurred with clozapine and olanzapine, but some weight gain also with quetiapine, risperidone, lithium, valproate and gabapentin; little or none with molindone, loxapine, carbamazepine and lamotrigine).
Findling RL, Johnson JL, McClellan J, Frazier JA, Vitiello B, Hamer RM, Lieberman JA, et al. (2010). Double-blind maintenance safety and effectiveness findings from the Treatment of Early-Onset Schizophrenia Spectrum (TEOSS) study. J Am Acad Child Adolesc Psychiatry. (119 youths with early onset schizophrenia were treated with olanzapine, risperidone or molindone for 8 weeks and 54 were treated in a maintenance study; those on molindone showed the highest numerical increases in ALT [increase of 3-5 U/L], but there were no drug discontinuations for liver disease).
Stocks JD, Taneja BK, Baroldi P, Findling RL. (2012). A phase 2a randomized, parallel-group, dose-ranging study of molindone in children with attention-deficit/hyperactivity disorder and persistent, serious conduct problems. J Child Adolesc Psychopharmacol. (Among 78 children with attention deficit syndrome treated with 1 of 4 doses of molindone for 12 weeks, adverse events included somnolence, weight gain, akathisia, sedation and abdominal pain, and there were “no clinically meaningful changes in laboratory” findings).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to antipsychotic drugs or molindone).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to molindone or other antipsychotic drugs).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. e7. PMID: 25754159 (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 were attributed to antipsychotic agents, including olanzapine [n=2] and quetiapine [n=3] but not molindone).
(2016). Drugs for psychotic disorders. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, toxicity and costs of antipsychotic drugs, mentions that molindone is a first generation agent and is less sedative and less likely to cause extrapyramidal symptoms than haloperidol and the phenothiazines; no mention of ALT elevations or hepatotoxicity).
Solmi M, Murru A, Pacchiarotti I, Undurraga J, Veronese N, Fornaro M, Stubbs B, et al. (2017). Safety, tolerability, and risks associated with first- and second-generation antipsychotics: a state-of-the-art clinical review. Ther Clin Risk Manag. (Safety and tolerability of antipsychotic medications in current use, mentions that liver damage is most common with chlorpromazine, olanzapine, clozapine, quetiapine and risperidone; hepatic injury related to molindone is not discussed).
Krause M, Zhu Y, Huhn M, Schneider-Thoma J, Bighelli I, Chaimani A, Leucht S. (2018). Efficacy, acceptability, and tolerability of antipsychotics in children and adolescents with schizophrenia: A network meta-analysis. Eur Neuropsychopharmacol. (Metaanalysis of published controlled trials of antipsychotic medications in children and adolescents mentions that molindone was superior to placebo and to haloperidol in studies of efficacy and was the best agent in terms of weight gain; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Molindone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Molindone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Molindone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Molindone)